# Thiazolidinediones

## OVERVIEW

The thiazolidinediones are a relatively new family of agents for type 2 diabetes that act by increasing insulin sensitivity through a unique mechanism of engagement of the so-called peroxisome proliferator-activated receptor gamma, PPAR-γ. Attachment of ligand to the PPAR-γ receptor activates a series of genes that are involved in glucose and fatty acid metabolism, the overall effect being an increase in insulin effect. The thiazolidinediones reduce blood glucose levels in patients with type 2 diabetes and act additively with other antidiabetic medications. Troglitazone was the first thiazolidinedione that received approval for use in the United States (January 1997). However, within a year of its approval, reports of severe liver injury and deaths from acute liver failure began to appear. Cautionary statements and recommendations for monitoring of ALT levels were made, but after more than two dozen reports of hepatic failure and the introduction of two new thiazolidinediones in 1999, troglitazone was withdrawn from use in 2000. The newer thiazolidinediones, rosiglitazone and pioglitazone, have been associated with only rare instances of acute liver injury. Both rosiglitazone and pioglitazone are linked to increased weight gain, heart failure and fracture risk and they are considered second-line agents for type 2 diabetes and recommended only after failure of metformin and lifestyle modifications.

All references on hepatotoxicity of the thiazolidinediones are given together at the end of this Overview section (updated June 2018). Representative cases are given in the records of specific agents.

Drug Class: Antidiabetic Agents

Drugs in the Subclass, Thiazolidinediones: Pioglitazone, Rosiglitazone, Troglitazone

## ANNOTATED BIBLIOGRAPHY

References updated: 06 June 2018

Zimmerman HJ. Oral hypoglycemic agents and other diabetes therapy. In, Zimmerman, HJ. Hepatotoxicity: the adverse effects of drugs and other chemicals on the liver. 2nd ed. Philadelphia: Lippincott, 1999, pp. 575-9. (Expert review of antidiabetic medications and liver injury published in 1999; discusses troglitazone which was associated with at least 2 cases of clinically apparent liver injury during premarketing trials and at least 8 within a year of its release, some of which were fatal).
De Marzio DH, Navarro VJ. Amiodarone. Hepatotoxicity of cardiovascular and antidiabetic drugs. In, Kaplowitz N, DeLeve LD, eds. Drug-induced liver disease. 3rd ed. Amsterdam: Elsevier, 2013, pp. 520-1. (Review of hepatotoxicity of thiazolidinediones mentions that in clinicial trials <1% of patients treated with pioglitazone or rosiglitazone had ALT elevations above 3 times ULN, but that isolated case reports of clinically apparent liver injury have appeared since their clinical release).
Powers AC, D'Alessio D. Thiazolidinediones. Endocrine pancreas and pharmacotherapy of diabetes mellitus and hypoglycemia. In, Brunton LL, Chabner BA, Knollman BC, eds. Goodman & Gilman’s the pharmacological basis of therapeutics. 12th ed. New York: McGraw-Hill, 2011, pp. 1259-61. (Textbook of pharmacology and therapeutics).
Spencer CM, Markham A. Troglitazone. Drugs 1997; 54: 89-101. (Review of pharmacology and clinical studies of troglitazone). 9211083
Inzucchi ES, Maggs DG, Spollett GR, Page SL, Rife FS, Walton V, Shulman GI. Efficacy and metabolic effects of metformin and troglitazone in type II diabetes. N Engl J Med 1998; 338: 867-72. (Crossover study of 3 months of metformin vs troglitazone in 29 patients with diabetes, with careful assessment of insulin action; similar lowering of glucose and HgA1c levels and the effects were additive; metformin decreased glucose production, troglitazone increased glucose disposal). 9516221
Schwartz S, Raskin P, Fonseca V, Graveline JF. Effect of troglitazone in insulin-treated patients with type II diabetes mellitus. N Engl J Med 1998; 338: 861-6. (Controlled trial of troglitazone in poorly controlled diabetics; ALT >3 times ULN occurred in 2 of 116 patients on 200 mg, 3 of 116 on 600 mg and 3 of 118 on placebo; one patient on 600 mg of troglitazone developed jaundice and ALT >10 times ULN). 9516220
Gitlin N, Julie NL, Spurr CL, Lim KN, Juarbe HM. Two cases of severe clinical and histologic hepatotoxicity associated with troglitazone. Ann Intern Med 1998; 129: 36-8. (44 and 62 year old women with severe hepatitis arising after 1.5 and 5 months of troglitazone therapy [peak bilirubin 20-29 mg/dL, ALT 18-50 times ULN , Alk P 2-20 times ULN], slow and incomplete recovery). 9652997
Neuschwander-Tetri BA, Isley WL, Oki JC, Ramrakhiani S, Quiason SG, Phillips NJ, Brunt EM. Troglitazone-induced hepatic failure leading to liver transplantation. A case report. Ann Intern Med 1998; 129: 38-41. (55 year old woman developed acute liver failure 3.5 months after starting troglitazone [bilirubin 8.7 mg/dL, ALT 798 U/L, Alk P 345 U/L], with progressive worsening leading to emergency liver transplant). 9652998
Vella A, de Groen PC, Dinneen BF. Fatal hepatoxicity associated with troglitazone. Ann Intern Med 1998; 129: 1080. (Letter describing case of acute liver failure in 85 year old man after 5 months of troglitazone [ALT 608 U/L, bilirubin 15.6 mg/dL], who subsequently died after 8 weeks of deterioration). 9867776
Watkins PB, Whitcomb RW. Hepatic dysfunction associated with troglitazone. N Engl J Med 1998; 338: 916-7. (Letter summarizing liver related adverse events in US clinical trials of troglitazone, including 2510 patients on drug and 475 on placebo; ALT levels >3 times ULN occurred in 1.9% of troglitazone vs 0.6% of placebo patients, elevations typically arose between 3 and 7 months, returning to normal by 2 months after stopping; 2 patients had jaundice). 9518284
Shibuya A, Watanabe M, Fujita Y, Saigenji K, Kuwao S, Takahashi H, Takeuchi H. An autopsy case of troglitazone-induced fulminant hepatitis. Diabetes Care 1998; 21: 2140-3. (58 year old Japanese man with severe hepatitis arising 4 months after starting troglitazone [bilirubin rising from 8.4 to 23 mg/dL, ALT 1655 U/L, Alk P 378 U/L], with liver failure and death 1 month later). 9839107
Misbin RI. Troglitazone-associated hepatic failure. Ann Intern Med 1999; 130 (4, pt 1): 330. (Letter from FDA in response to 3 reports in the Annals; FDA received 560 reports of troglitazone associated hepatotoxicity, including 27 with acute liver failure [3 transplanted]. In clinical trials, 0.8% of patients stopped troglitazone because of ALT elevations; provides table of results of a fatal case in whom ALT rose from 89 to 933 U/L between weeks 57 and 90 and suggested that all elevations [not just those >3 times ULN] should be closely followed). 10068399
Herrine SK, Choudhary C. Severe hepatotoxicity associated with troglitazone. Ann Intern Med 1999; 130: 163-4. (52 year old woman developed hepatitis 20 weeks after starting troglitazone [bilirubin 28.9 mg/dL, ALT 1227 U/L, Alk P 216 U/L, protime 15.2 sec], followed by liver failure and death). 10068372
Balfour JAB, Plosker GL. Rosiglitazone. Drugs 1999; 57: 921-30. (Review of basic and clinical pharmacology, preclinical studies and phase I-III clinical trials of rosiglitazone; side effects in US trials included hypoglycemia when combined with other agents, edema in 4.8% [1.2% with placebo] and abnormal ALT levels >3 times ULN in 0.26% [4/1526] compared to 0.25% in placebo recipients; no mention of clinically apparent liver injury). 10400405
Gillies PS, Dunn CJ. Pioglitazone. Drugs 2000; 60: 333-43. (Review of basic and clinical pharmacology, preclinical studies and phase I-III clinical trials of pioglitazone; hypoglycemia was no more common than with comparative agents and pooled data on >4500 patients found ALT elevations >3 times ULN in 0.17% compared to 0.18% with placebo and 0.48% with sulfonylureas or metformin; no mention of clinically apparent liver injury). 10983737
Forman LM, Simmons DA, Diamond RH. Hepatic failure in a patient taking rosiglitazone. Ann Intern Med 2000; 132: 118-21. (69 year old man with advanced cardiac disease developed evidence of acute liver failure after 3 weeks of rosiglitazone [bilirubin 3.8 mg/dL, ALT 1890 U/L, Alk P 210 U/L, INR 9.6], with rapid reversal on stopping). 10644272
Isley WL, Oki JC. Rosiglitazone and liver failure. Ann Intern Med 2000; 133: 393. (Letter in response to Forman et al. [2000] questioning the role of rosiglitazone and raising the possibility of hypotension causing the liver injury). 10979889
Freid J, Everitt D, Boscia J. Rosiglitazone and hepatic failure. Ann Intern Med 2000; 132: 164. (Letter questioning the role of rosiglitazone in case described by Forman et al. [2000], stating that history of cardiac instability and ALT level of 11,000 U/L falling to normal in 9 days is typical of ischemia). 10644281
Al-Salman J, Arjomand H, Kemp DG, Mittal M. Hepatocellular injury in a patient receiving rosiglitazone. A case report. Ann Intern Med 2000; 132: 121-4. (61 year old developed fatigue and jaundice 8 days after starting rosiglitazone [bilirubin 9.6 mg/dL, ALT 1370 U/L, Alk P 331 U/L], resolving within 2 months of stopping). 10644273
Jagannath S, Rai R. Rapid-onset subfulminant liver failure associated with troglitazone. Ann Intern Med 2000; 132: 677. (Letter describing 47 year old man who developed jaundice and cholestatic hepatitis on liver biopsy arising after only 4 doses of troglitazone, with few specifics given). 10766693
Prendergast KA, Berg CL, Wisniewski R. Troglitazone-associated hepatotoxicity treated successfully with steroids. Ann Intern Med 2000; 133: 751. (Letter describing 59 year old man who developed hepatitis 1 year after starting troglitazone [bilirubin rising to 18 mg/dL, ALT to 1400 U/L], treated with prednisone with rapid and ultimately complete improvement; ANA 1:80). 11074925
Ravinuthala RS, Nori U. Rosiglitazone toxicity. Ann Intern Med 2000; 133: 658. (58 year old developed jaundice 3 weeks after starting rosiglitazone [bilirubin 2.4 mg/dL, ALT 314 U/L], recovering within 4 weeks of stopping). 11033603
Hachey DM, O.Neil MP, Force RW. Isolated elevation of alkaline phosphatase level associated with rosiglitazone. Ann Intern Med 2000; 133: 752. (47 year old woman with isolated elevation of Alk P to 656 U/L, but normal ALT after 4 months of rosiglitazone, 2 weeks after stopping all tests were normal). 11074926
Booth AM, Caldwell SH, Iezzoni JC. Troglitazone-associated hepatic failure. Am J Gastroenterol 2000; 95: 5557-8. (68 year old woman developed acute liver failure and died 7 months after starting troglitazone [bilirubin 11 mg/dL, ALT 1125 U/L], autopsy showing massive collapse). 10685776
Kohlroser J, Mathai J, Reichheld J, Banner BR, Bonkovsky HL. Hepatotoxicity due to troglitazone: report of two cases and review of adverse vents reported to the United States Food and Drug Administration. Am J Gastroenterol 2000; 95: 272-6. (A 48 year old woman and 62 year old man with onset of liver injury after 5 and 2 months of troglitazone therapy [bilirubin 1.5 and 3.7 mg/dL, ALT 653 and 253 U/L, Alk P not available and 253 U/L], with rapid recovery upon stopping; reviewed FDA reports: cases had female predominance, duration 6-195 days, hepatocellular injury often severe). 10638596
Arioglu E, Duncan-Morin J, Sebring N, Rother KI, Gottlieb N, Lieberman J, Herion D, et al. Efficacy and safety of troglitazone in the treatment of lipodystrophy syndromes. Ann Intern Med 2000; 133: 263-74. (Open label study of troglitazone in 13 patients with lipoatrophic diabetes showed improvements in HgA1c and increase in subcutaneous fat; one patient developed fatigue and ALT elevation [10 times ULN] after 10 months of therapy, resolving 3 months after stopping). 10929166
Murphy EJ, Davern TJ, Shakil O, Shick L, Masharani U, Chow H, Freise C, et al., and the Acute Liver Failure Study Group. Troglitazone-induced fulminant hepatitis failure. Dig Dis Sci 2000; 45: 549-53. (Description of 3 cases of acute liver failure attributable to troglitazone representing 5% of all cases admitted to the Acute Liver Failure Study Group; ages 55-61, all female, onset after 3-9 months [bilirubin progressively rising, ALT 1281-2740 U/L, Alk P 167-174 U/L], 2 had liver transplant, 1 died without). 10749332
Bell DS, Ovalle F. Late-onset troglitazone-induced hepatic dysfunction. Diabetes Care 2000; 23: 128-9. (76 year old man developed rise in ALT to 64 U/L without symptoms or jaundice after 18 months of troglitazone, reversed upon stopping within 3 months). 10857986
Schiano T, Dolehide K, Hart J, Baker AL. Severe but reversible hepatitis induced by troglitazone. Dig Dis Sci 2000; 45: 1039-42. (63 year old man developed hepatitis 6 months after starting troglitazone [bilirubin 13.2 mg/dL, ALT 1961 U/L, Alk P 213 U/L], resolving within 4 months of stopping). 10795774
Li H, Heller DS, Leevy CB, Zierer KG, Klein KM. Troglitazone-induced fulminant hepatitis. Report of a case with autopsy findings. J Diabet Complic 2000; 14: 175-7. (71 year old man developed fatal hepatitis after 10 months of troglitazone therapy with jaundice, rash, hepatic coma and multiorgan failure [bilirubin 36 mg/dL, ALT 318 U/L, Alk P 147 U/L], autopsy showing massive necrosis). 10989325
Malik A, Prasad P, Saboorian MH, Thiele DL, Maler PF. Hepatic injury due to troglitazone. Dig Dis Sci 2000; 45: 210-4. (Two 51 year old women who received troglitazone for 5-6 months, developed hepatitis [bilirubin 5.9-8.0 mg/dL, ALT 718-1230 U/L, Alk P 182-410 U/L], resolving in 7-8 weeks of stopping). 10695637
Fukano M, Amano S, Sato J, Yamamoto K, Adachi H, Okabe H, Fujiyama Y, et al. Subacute hepatic failure associated with a new antidiabetic agent, troglitazone: a case report with autopsy examination. Human Pathol 2000; 31: 250-3. (63 year old woman developed malaise 2 months after starting troglitazone and jaundice after 4 months, [bilirubin 15.8 mg/dL, ALT 45 U/L, Alk P 80 U/L, protime 48%], with subsequent decompensation and death. 10685643
Krische D. The glitazones: proceed with caution. West J Med 2000; 173: 54-7. (Editorial suggesting caution in using thiazolindinediones after withdrawal of troglitazone for hepatotoxicity; early results suggest less of a problem with rosiglitazone and pioglitazone). 10903299
Tolman KG. Thiazolidinedione hepatotoxicity: a class effect? Int J Clin Pract Suppl 2000; (113): 29-34. (Review of hepatotoxicity of thiazolidinediones stressing differences with different agents; ALT elevations above 3 times ULN occurred in 1.9% of troglitazone, 0.26% pioglitazone, 0.25% rosiglitazone, and 0.25% placebo recipients; ALT above 10 times ULN occurred in 12/2510 troglitazone treated patients compared to no patient on pioglitazone and one on rosiglitazone; multiple cases of acute liver failure attributed to troglitazone, few if any to the others). 11965828
Biswas P, Wilton LV, Shakir SA. Troglitazone and liver function abnormalities: lessons from a prescription event monitoring study and spontaneous reporting. Drug Saf 2001; 24: 149-54. (Troglitazone was available in the UK for only 3 months; a cohort database study identified 2556 prescriptions written between Oct-Dec 1997, questionnaires returned on 1541 which identified 5 cases of liver injury possibly due to troglitazone, but none severe or fatal). 11235818
Graham DJ, Drinkard CR, Shatin D, Tsong Y, Burgess MJ. Liver enzyme monitoring in patients treated with troglitazone. JAMA 2001; 286: 831-3. (Analysis of health database on whether patients given troglitazone had routine ALT monitoring as recommended by FDA; baseline testing rose from 15-45% and early monitoring from <5% to 33%, but fewer than 5% received all recommended testing; thus, FDA guidelines on monitoring were rarely followed). 11497537
Chaudhry MU, Simmons DL. Case of the month. Hepatic and renal failure in a patient taking troglitazone and metformin. J Ark Med Soc 2001; 98: 16-9. (54 year old man developed jaundice 5 years after starting metformin and 18 months after starting troglitazone shortly after episode of bloody diarrhea and hypotension [bilirubin 17 mg/dL, ALT 574 U/L, Alk P 125 U/L], resolving after stopping oral agents and stabilization of heart disease). 11452755
Lenhard MJ, Funk WB. Failure to develop hepatic injury from rosiglitazone in a patient with a history of troglitazone-induced hepatitis. Diabetes Care 2001; 24: 168-9. (36 year old woman developed jaundice and hepatitis 4 months after starting troglitazone, from which she recovered and then received rosiglitazone which she tolerated for 10 months with regular monitoring of ALT). 11194222
Gale EA. Lessons from the glitazones: a story of drug development. Lancet 2001; 357: 1870-5. PubMed Citation (https://www.ncbi.nlm.nih.gov/pubmed/%2011410214) (History of troglitazone approval and usefulness of thiazolidinediones from a British viewpoint, the agent having been withdrawn within weeks of its approval in the UK, compared to voluntary withdrawal after 3 years in the US).
Maeda K. Hepatocellular injury in a patient receiving pioglitazone. Ann Intern Med 2001; 135: 306. PubMed Citation (https://www.ncbi.nlm.nih.gov/pubmed/%2011511159) (67 year old man had asymptomatic elevations in ALT [339 U/L], Alk P [~3 times ULN], but normal bilirubin [0.6 mg/dL] after 7 months of troglitazone therapy, resolving within 2 weeks of stopping).
Gouda HE, Khan A, Schwartz J, Cohen RI. Liver failure in a patient treated with long-term rosiglitazone therapy. Am J Med 2001; 111: 584-5. (82 year old man developed fatal acute liver failure 1 year after starting rosiglitazone [bilirubin 2.1 rising to 7.2 mg/dL, ALT 4214 U/L, LDH 12,638 U/L]; possibility of ischemia was not completely ruled out). 11705443
Caldwell SH, Hespenheide EE, von Borstel RW. Myositis, microvesicular hepatitis, and progression to cirrhosis from troglitazone added to simvastatin. Dig Dis Sci 2001; 46: 376-8. (68 year old woman developed jaundice and ascites 8 weeks after starting troglitazone [bilirubin 4.5 mg/dL, ALT 437 U/L, Alk P 109 U/L, CK 14,300 U/L, platelet 88,000 and protime 18 sec], biopsy showing cirrhosis with fat, partial reversal with stopping). 11281188
Scheen AJ. Thiazolidinediones and liver toxicity. Diabetes Metab 2001; 27: 305-14. (Review of hepatotoxicity thiazolidinediones; in large clinical trials, rate of ALT elevations of >3 times ULN with troglitazone was 1.9%, >10 times in 0.5%, and >30 times in 0.2%; rates for rosiglitazone were 0.25%, 0.02% and 0%; for pioglitazone 0.25%, 0%, 0%; for placebo 0.25-0.6%, 0%, 0%; careful discussion of 2 case reports of acute liver failure from rosiglitazone suggesting that both had other causes; no case reports of liver failure from pioglitazone). 11431595
McMorran M, Vu D. Rosiglitazone (Avandia): hepatic, cardiac and hematological reactions. CMAJ 2001; 165: 82-3, 86-7. English, French. (Editorial and alert on the potential adverse effects of rosiglitazone). 11468963
Scheen AJ. Hepatotoxicity with thiazolidinediones. Is it a class effect? Drug Saf 2001; 24: 873-88. (Review of hepatotoxicity of thiazolidinediones; in large clinical trials, rate of ALT elevations of >3 times ULN with troglitazone was 1.9%, >10 times in 0.5%, and >30 times ULN in 0.2%; rates for rosiglitazone were 0.25%, 0.02% and 0%; for pioglitazone 0.25%, 0%, 0%; for placebo 0.25-0.6%, 0%, 0%; a total of 61 reports of acute liver failure attributed to troglitazone reported to FDA). 11735645
Faich GA, Moseley RH. Troglitazone (Rezulin) and hepatic injury. Pharmacoepidemiol Drug Saf 2001; 10: 537-47. (Analysis of cases of troglitazone associated severe liver disease reported to FDA 1997-2000; 83 cases among 1.6 million person-years of exposure: 1:20,000 person-years. Decrease in reports over time interpreted as showing effectiveness of ALT surveillance). 11828837
Menon KVN, Angulo P, Lindor KD. Severe cholestatic hepatitis from troglitazone in a patient with nonalcoholic steatohepatitis and diabetes mellitus. Am J Gastroenterol 2001; 96: 1631-4. (34 year old obese woman with nonalcoholic steatohepatitis developed jaundice 17 months after starting troglitazone [bilirubin 17.9 mg/dL, ALT 178 U/L and Alk P 1307 U/L], with slow recovery upon stopping). 11374713
Lebovitz HE, Kreider M, Freed MI. Evaluation of liver function in type 2 diabetic patients during clinical trials. Diabetes Care 2002; 25: 815-2002. (Analysis on >6000 patients in clinical trials found ALT levels >3 times ULN in 1.9% of troglitazone, 0.32% of rosiglitazone, 0.26% of pioglitazone, 0.4% of sulfonylurea/metformin, and 0.17% of placebo treated patients; no mention of severe liver toxicity or jaundice). 11978674
May LD, Lefkowitch JH, Kram MT, Rubin DE. Mixed hepatocellular-cholestatic liver injury after pioglitazone therapy. Ann Intern Med 2002; 136: 449-52. (49 year old developed jaundice 6 months after starting pioglitazone and 2 months after dose increase [bilirubin 5.7 mg/dL, ALT 218 U/L, Alk P 312 U/L], resolving within 1 month of stopping). 11900497
Nierenberg DW. "Did this drug cause my patient's hepatitis?" and related questions. Ann Intern Med 2002; 136: 480-3. (Informal commentary on report by May et al. regarding pioglitazone). 11900502
Pinto AG, Cummings OW, Chalasani N. Severe but reversible cholestatic liver injury after pioglitazone therapy. Ann Intern Med 2002; 137: 857. (49 year old woman developed jaundice 7 weeks after starting pioglitazone [bilirubin rising to 34.2 mg/dL, ALT 84, Alk P ~2 times ULN], with slow recovery over 6 months). 12435231
Nagasaka S, Abe T, Kawakami A, Kusaka I, Nakamura T, Ishikawa S, Saito T, et al. Pioglitazone-induced hepatic injury in a patient previously receiving troglitazone with success. Diabetes Medicine 2002; 19: 344-8. (62 year old woman who had received troglitazone for several years without problems developed elevated ALT [508 U/L] and LDH [1085 U/L] without jaundice 1 month after starting pioglitazone, asymptomatic and rapidly resolving on stopping). 11943013
Dhawan M, Agrawal R, Ravi J, Gulati S, Silverman J, Nathan G, Raab S, et al. Rosiglitane-induced granulomatous hepatitis. J Clin Gastroenterol 2002; 34: 582-4. (37 year old developed liver injury 15 months after starting rosiglitazone [bilirubin 5.9 mg/dL, ALT 82 U/L, Alk P 125 U/L], resolving within 2 months of stopping; biopsy showed granulomas). 11960075
Bonkovsky HL, Azar R, Bird S, Szabo G, Banner B. Severe cholestatic hepatitis caused by thiazolidinediones: risks associated with substituting rosiglitazone for troglitazone. Dig Dis Sci 2002; 47: 1632-7. (56 year old woman developed mild liver injury 2 years after starting troglitazone [bilirubin 2.3 mg/dL, ALT 33 U/L, Alk P 290 U/L], and then worsened when she switched to rosiglitazone [bilirubin 23 mg/dL, ALT 84 U/L, Alk P 830 U/L], with subsequent slow, partial recovery on stopping thiazolidinediones while being treated with prednisone, azathioprine and ursodiol). 12141828
Chase MP, Yarze JC. Pioglitazone-associated fulminant hepatic failure. Am J Gastroenterol 2002; 97: 502-3. (78 year old man developed severe hepatitis after 2 months of pioglitazone therapy [bilirubin 4.4 mg/dL, ALT 2303 U/L, Alk P 201 U/L, protime 24 sec], treated with prednisone and ultimately recovering). 11866308
Chan KA, Truman A, Gurwitz JH, Hurley JS, Martinson D, Platt R, Everhart JE, et al. A cohort study of the incidence of serious acute liver injury in diabetic patients treated with hypoglycemic agents. Arch Intern Med 2003; 163: 728-34. (Retrospective cohort study of 171,264 health plan members who received therapy for diabetes over 2 years; found 35 cases of acute liver failure of unknown cause, standardized incidence per 1000 person-years was 0.15 for patients on insulin, 0.08 for sulfonylureas, 0.12 for metformin and 0.10 for troglitazone). 12639207
Graham DJ, Drinkard CR, Shatin D. Incidence of idiopathic acute liver failure and hospitalized liver injury in patients treated with troglitazone. Am J Gastroenterol 2003; 98: 175-9. (Analysis of databases on 3 million persons for use of troglitazone [n=75,680] and acute liver injury attributable to drug [n=5] and one acute liver failure case, ~240 cases per million-person years of therapy). 12526954
Graham DJ, Green L, Senior JR, Nourjah P. Troglitazone-induced liver failure: a case study. Am J Med 2003; 114: 299-306. (Analysis of 94 cases of acute liver failure attributed to troglitazone reported to FDA, average age 63 years, 67% female, onset 3 days to 2 years after starting; hepatocellular enzyme pattern in 85%, highly fatal [13% spontaneous recovery], often with rapid progression [<1 month]). 12681458
Hisamochi A, Kumashiro R, Koga Y, et al. A case of drug-induced liver injury related to pioglitazone. Nippon Shokakibyo Gakkai Zasshi 2003; 100: 333-6. (Case report of acute anicteric hepatitis arising after 120 days of pioglitazone [bilirubin 0.4 mg/dL, ALT 583 U/L, Alk P 305 U/L], and rapid recovery with stopping). 12696176
Tolman KG, Chandramouli J. Hepatotoxicity of the thiazolidinediones. Clin Liver Dis 2003; 7: 369-79, vi. (Review of hepatotoxicity of thiazolidinediones). 12879989
Watanabe I, Tomita A, Shimizu M, Sugawara M, Yawsumo H, Koishi R, Takahashi T, et al. A study to survey susceptible genetic factors responsible for troglitazone-associated hepatotoxicity in Japanese patients with type 2 diabetes mellitus. Clin Pharmacol Ther 2003; 73: 435-55. (Analysis of 51 candidate genes in 110 patients treated with troglitazone, 25 of whom developed abnormal ALT levels [range 360-1905 U/L]; association found with glutathione-S-transferase polymorphisms [odds ratio 3.7: 40% of cases vs 15% of controls]). 12732844
Isley WL. Hepatotoxicity of thiazolidinediones. Expert Opin Drug Saf 2003; 2: 581-6. (Review of liver injury from thiazolidinediones, concluding that rosiglitazone and pioglitazone have a larger margin of safety than troglitazone for liver toxicity). 14585066
Kessler W, Johnson B, Yoo HY. Acute fulminant hepatic failure associated with the use of rosiglitazone. Am J Gastroenterol 2003; 98 (Suppl 2): S212. [Abstract]. Not in PubMed (60 year old woman developed jaundice 4 weeks after starting rosiglitazone, aminotransferase levels “up to 5,000 U/L”, underwent liver transplantation; few details given).
Farley-Hills E, Sivasankar R, Martin M. Fatal liver failure associated with pioglitazone. BMJ 2004; 329: 429. Not in PubMed (63 year old man developed jaundice 10 weeks after starting pioglitazone [bilirubin 30.5 mg/dL, ALT 1984 U/L, Alk P 472 U/L, protime 56 sec], progressing to hepatic failure and death; autopsy showed extensive fibrosis and Mallory bodies, despite lack of history of alcohol abuse).
Arotçarena R, Bigué JP, Etcharry F, Pariente A. [Pioglitazone-induced acute severe hepatitis] Gastroenterol Clin Biol 2004; 28 (6-7 Pt 1): 610-1. French. (Case of jaundice arising 6 weeks after starting pioglitazone [bilirubin 15.8 mg/dL, ALT 73 times ULN, Alk P 2 times ULN], with subsequent worsening and period of ascites, but ultimate recovery in 2 months). 15243398
Marcy TR, Britton ML, Blevins SM. Second-generation thiazolidinediones and hepatotoxicity. Ann Pharmacother 2004; 38: 1419-23. (38 year old woman on pioglitazone intermittently for 6 months developed fatigue, nausea and jaundice [bilirubin 3.1 mg/dL, ALT 490 U/L, Alk P 851 U/L], resolving within 3 months of stopping). 15266041
Russo MW, Galanko JA, Shrestha R, Fried MW, Watkins P. Liver transplantation for acute liver failure from drug-induced liver injury in the United States. Liver Transpl 2004; 10: 1018-23. (Among ~50,000 liver transplants done in the US between 1990 and 2002, 137 [0.2%] were done for idiosyncratic drug induced acute liver failure, 4 of which were attributed to troglitazone). 15390328
Misbin RI. Evaluating the safety of diabetes drugs. Perspective of a Food and Drug Administration insider. Diabetes Care 2005; 28: 2573-75. (History of evaluation, approval and subsequent issues with complications of 3 antidiabetic medications; metformin and lactic acidosis, the thiazolidinediones and acute liver failure, and pioglitazone and congestive heart failure). 16186303
Menees SB, Anderson MA, Chensue SW, Moseley RH. Hepatic injury in a patient taking rosiglitazone. J Clin Gastroenterol 2005; 39: 638-40. (52 year old man developed liver injury 11 months after starting rosiglitazone therapy [bilirubin 19.1 mg/dL, ALT 111 U/L, Alk P 202 U/L], with subsequent progression to liver failure with varices, ascites and persistent jaundice; death from sepsis). 16000935
Rajagopalan R, Iyer S, Perez A. Comparison of pioglitazone with other antidiabetic drugs for associated incidence of liver failure: no evidence of increased risk of liver failure with pioglitazone. Diab Obes Metabol 2005; 7: 161-9. (Review of healthcare database of patients on monotherapy with pioglitazone [n=1939], rosiglitazone [2290], sulfonylureas [6923] or metformin [8547] for annual rates of hepatitis or liver failure, which were not different among the different agents [0.5%, 0.4%, 0.9% and 0.7%]). 15715889
Chojkier M. Troglitazone and liver injury: in search of answers. Hepatology 2005; 41: 237-46. (Editorial discussing mechanism of troglitazone hepatotoxicity; no accumulation in liver, parent compound rapidly metabolized and in vitro and in vivo it does not stimulate oxidative stress, injure mitochondria, induce apoptosis or inhibit bile transport. Mechanism of injury remains unclear, but likely to be metabolic idiosyncrasy). 15657914
Su DH, Lai MY, Wu HP. Liver failure in a patient receiving rosiglitazone therapy. Diabet Med 2006; 23: 105-6. (60 year old woman developed jaundice, 11 months after adding rosiglitazone to glyburide and metformin [bilirubin rising from 13.8 to 22.2 mg/dL, ALT 1152 U/L, HBsAg positive], resolving within 4 months of stopping). 16409577
Spiller HA, Sawyer TS. Toxicology of oral antidiabetic medications. Am J Health Syst Pharm 2006; 63: 929-38. (Review on safety of oral antidiabetic medications focusing upon hypoglycemia and overdose; little information on hepatotoxicity). 16675650
Wang C-H, Leung C-H, Liu S-C, Chung C-H. Safety and effectiveness of rosiglitazone in type 2 diabetes patients with nonalcoholic fatty liver disease. J Formos Med Assoc 2006; 105: 743-52. (Rosiglitazone therapy was associated with normalization of ALT levels in 1/3rd of 68 patients with fatty liver disease; no cases of hepatotoxicity). 16959622
Masubuchi Y. Metabolic and non-metabolic factors determining troglitazone hepatotoxicity: a review. Drug Metab Pharmacokinet 2006; 21: 347-56. (Review of mechanisms of hepatotoxicity of troglitazone, suggesting mitochondrial membrane permeability abnormalities). 17072088
Kawamori R, Kadowaki T, Onji M, Seino Y, Akanuma Y; PRACTICAL Study Group. Hepatic safety profile and glycemic control of pioglitazone in more than 20,000 patients with type 2 diabetes mellitus: postmarketing surveillance study in Japan. Diabetes Res Clin Pract 2007; 76: 229-35. (Prospective evaluation of 24,993 patients taking pioglitazone; average ALT declined by 3 U/L [10 U/L in patients with known fatty liver]; 19 serious liver reactions, 4 with jaundice, but most could be attributed to other causes and no case of liver failure). 17109986
Martínez Odriozola P, Ibarmia Lahuerta J, Gutiérrez Macías A, de la Villa FM. [A new case: pioglitazone hepatotoxicity] Med Clin (Barc). 2007; 129: 158-9. Spanish. (58 year old woman developed fatigue and elevation in ALT [2,760 U/L] with normal alkaline phosphatase and bilirubin 2 months after starting pioglitazone therapy, and resolving within a few weeks of stopping). 17663974
Chiang CK, Ho TI, Peng YS, Hsu SP, Pai MF, Yang SY, Hung KY, Wu KD. Rosiglitazone in diabetes control in hemodialysis patients with and without viral hepatitis infection: effectiveness and side effects. Diabetes Care 2007; 30: 3-7. (Among 78 diabetic patients on hemodialysis treated with rosiglitazone [including 12 with hepatitis B and 13 with hepatitis C], there were no significant changes in ALT, AST or Alk P levels during therapy). 17192324
Ong MMK, Latchoumycandane C, Boelsterli UA. Troglitazone-induced hepatic necrosis in an animal model of silent genetic mitochondrial abnormalities. Toxicol Sci 2007; 97: 205-213. (Mice with Sod2 knock out heterozygosity developed mild hepatic injury after 2 weeks of troglitazone therapy, suggesting increased susceptibility to oxidative mitochondrial damage). 17150972
Jaeschke H. Troglitazone hepatotoxicity: are we getting closer to understanding idiosyncratic liver injury? Toxicol Sci 2007; 97: 1-3. (Editorial reviewing various hypotheses on mechanisms of injury by troglitazone). 17575588
El-Naggar MHM, Helmy A, Moawad M, Al-Omary M, Al-Kadhi Y, Habib B. Late-onset rosiglitazone-associated acute liver failure in a patient with Hodgkin.s lymphoma. Ann Pharmacother 2008; 42: 713-8. (52 year old man developed fever and fatigue 11 months after starting rosiglitazone with pancreatitis, evolving cholestasis and Hodgkin's lymphoma [bilirubin rising from 1.1 to 49 mg/dL, ALT 33 to 488 U/L, Alk P 236 to 832 U/L], possibly Hodgkin's disease related cholestasis). 18397974
Aithal GP, Thomas JA, Kaye PV, Lawson A, Ryder SD, Spendlove I, Austin AS, et al. Randomized, placebo-controlled trial of pioglitazone in nondiabetic subjects with nonalcoholic steatohepatitis. Gastroenterology 2008; 135: 1176-84. (74 nondiabetic patients with nonalcoholic steatohepatitis randomized to received pioglitazone or placebo; the treatment group showed improved histology and biochemical parameters, with no significant hepatic adverse events). 18718471
Julie NL, Julie IM, Kende AI, Wilson GL. Mitochondrial dysfunction and delayed hepatotoxicity: another lesson from troglitazone. Diabetologia 2008; 51: 2108-16. (Long term follow up on 11 cases of troglitazone hepatotoxicity, all of which had some degree of residual liver injury or cirrhosis which the authors interpreted as evidence of delayed mitochondrial dysfunction). 18726085
Chalasani N, Fontana RJ, Bonkovsky HL, Watkins PB, Davern T, Serrano J, Yang H, Rochon J; Drug Induced Liver Injury Network (DILIN). Causes, clinical features, and outcomes from a prospective study of drug-induced liver injury in the United States. Gastroenterology 2008; 135: 1924-34. (Among 300 cases of drug induced liver disease in the US collected between 2004 and 2008, no case was attributed to rosiglitazone or pioglitazone). 18955056
Tolman KG, Freston JW, Kupfer S, Perez A. Liver safety in patients with type 2 diabetes treated with pioglitazone: results from a 3-year, randomized, comparator-controlled study in the US. Drug Saf 2009; 32: 787-800. (Observational cohort study of 2097 patients with diabetes randomized to receive either glyburide or pioglitazone and followed for 3 years; adverse hepatic events [ALT > 3 times ULN] occurred in 0.38% of the glyburide group, but in none of the pioglitazone group). 19670918
Rizos CV, Elisaf MS, Mikhailidis DP, Liberopoulos EN. How safe is the use of thiazolidinediones in clinical practice? Exp Opin Drug Saf 2009; 8: 15-32. (Review of the safety of thiazolidinediones; the authors argue that the toxicity seen with troglitazone is not a class effect). 19236215
Floyd JS, Barbehenn E, Lurie P, Wolfe SM. Case series of liver failure associated with rosiglitazone and pioglitazone. Pharmacoepidemiol Drug Saf 2009; 18: 1238-43. (Analysis of adverse event reports to FDA from 1997 and 2006 identified 11 cases of liver failure attributable to rosiglitazone and 10 to pioglitazone; average age 66 years, latency 9 weeks [IQ ranges bilirubin 4.2-29.2 mg/dL, ALT 463-2144 U/L, Alk P 243-511 U/L], 80% mortality; authors estimated incidence of acute liver failure to be ~1.7 per million patient-years of exposure to either agent). 19623674
Osei SY, Koro CE, Cobitz AR, Kolatkar NS, Stender M. Commentary on 'Case series of liver failure associated with rosiglitazone and pioglitazone' by Floyd et al. Pharmacoepidemiol Drug Saf 2009; 18: 1244-6. (Commentary on Floyd et al. [2009] from the sponsor of rosiglitazone questioned whether the cases were related to rosiglitazone; among 26,983 subjects monitored in clinical trials of rosiglitazone, there were no cases of hepatic failure and few with ALT elevations >10 times ULN [0.02 per 100-patient years]). 19655316
Beiderbeck AB, Sakaguchi M. Commentary on 'Case series of liver failure associated with rosiglitazone and pioglitazone' by James Floyd et al. Pharmacoepidemiol Drug Saf 2009; 18: 1247-9. (Commentary on Floyd et al. [2009] from the sponsor of pioglitazone questioned whether the cases were related to pioglitazone as opposed to the background rate of acute liver failure in the population, particularly among patients with diabetes). 19842093
Shah P, Mudaliar S. Pioglitazone: side effect and safety profile. Expert Opin Drug Saf 2010; 9: 347-54. (Review of the side effects of pioglitazone mentioning that serum ALT elevations greater than 3 times the ULN occurred in 0.26% of 1526 pioglitazone treated, but also in 0.25% of 793 placebo treated patients; no discussion of clinically apparent cases of liver injury). 20175701
Agarwal VK, McHutchison JG, Hoofnagle JH; Drug-Induced Liver Injury Network. Important elements for the diagnosis of drug-induced liver injury. Clin Gastroenterol Hepatol 2010; 8: 463-70. ( Analysis of 50 published cases reports of hepatotoxicity from the thiazolidinediones for completeness of data elements, finding that most reports failed to provide a large number elements needed to assess causality). 20170750
Sanyal AJ, Chalasani N, Kowdley KV, McCullough A, Diehl AM, Bass NM, Neuschwander-Tetri BA, et al.; NASH CRN. Pioglitazone, Vitamin E, or placebo for nonalcoholic steatohepatitis. N Engl J Med 2010; 362: 1675-85. (Controlled trial of 2 year course of pioglitazone vs placebo in 167 patients with nonalcoholic steatohepatitis showed significant improvements in serum ALT levels and liver histology and no case of hepatotoxicity). 20427778
Ratziu V, Charlotte F, Bernhardt C, Giral P, Halbron M, Lenaour G, Hartmann-Heurtier A, et al.; LIDO Study Group. Long-term efficacy of rosiglitazone in nonalcoholic steatohepatitis: results of the fatty liver improvement by rosiglitazone therapy (FLIRT 2) extension trial. Hepatology 2010; 51: 445-53. (53 patients who participated in a one year placebo controlled trial of rosiglitazone for nonalcoholic steatohepatitis were treated for an additional 2 years; none developed evidence of hepatotoxicity). 19877169
Reuben A, Koch DG, Lee WM; Acute Liver Failure Study Group. Drug-induced acute liver failure: results of a U.S. multicenter, prospective study. Hepatology 2010; 52: 2065-76. (Among 1198 patients with acute liver failure enrolled in a US prospective study between 1998 and 2007, 133 [11%] were attributed to drug induced liver injury, of which 4 were due to troglitazone, but none to other antidiabetic medications). 20949552
Tolman KG. The safety of thiazolidinediones. Expert Opin Drug Saf 2011; 10: 419-28. ( Review of side effects of pioglitazone and rosiglitazone indicating that clinically apparent liver injury from these agents is rare and idiosyncratic, and suggests that acute liver failure is no more common with these agents than other antidiabetic medications). 21366501
Ikeda T. Drug-induced idiosyncratic hepatotoxicity: prevention strategy developed after the troglitazone case. Drug Metab Pharmacokinet 2011; 26: 60-70. (Review of mechanisms of troglitazone hepatotoxicity and what features might have predicted these effects, a major factor being the amount of covalent binding of the drug to intracellular proteins in in vitro systems). 21178300
Berthet S, Olivier P, Montastruc JL, Lapeyre-Mestre M. Drug safety of rosiglitazone and pioglitazone in France: a study using the French PharmacoVigilance database. BMC Clin Pharmacol 2011; 11: 5. (Analysis of French Pharmacovigilance reporting system found that pioglitazone and rosiglitazone, in comparison to other agents, were associated with increased risk for adverse event reports for edema and heart failure, but not liver injury). 21609444
Drugs for type 2 diabetes. Treat Guidel Med Lett 2011; 9 (108): 47-54. (Concise review of role of current antidiabetic medications in management of type 2 diabetes). 21778966
Kung J, Henry RR. Thiazolidinedione safety. Expert Opin Drug Saf 2012; 11: 565-79. (Review of adverse events of thiazolidinediones, focusing upon cardiac complications and the risk of myocaridal infaction, particularly with rosiglitazone; pioglitazone has been implicated in at least 10 cases of liver failure, but prospective studies have shown no increase in hepatotoxicity; nevertheless, monitoring of serum ALT levels is recommended). 22616948
Björnsson ES, Bergmann OM, Björnsson HK, Kvaran RB, Olafsson S. Incidence, presentation and outcomes in patients with drug-induced liver injury in the general population of Iceland. Gastroenterology 2013; 144: 1419-25. (In a population based study of drug induced liver injury from Iceland, 96 cases were identified over a 2 year period, none of which were attributed to a thiazolidinedione or other antidiabetic medication). 23419359
Hernández N, Bessone F, Sánchez A, di Pace M, Brahm J, Zapata R, A Chirino R, et al. Profile of idiosyncratic drug induced liver injury in Latin America. An analysis of published reports. Ann Hepatol 2014; 13: 231-9. (Systematic review of literature of drug induced liver injury from Latin American countries published between 1996 and 2012 identified 176 cases, but none of the cases were attributed to a thiazolidinedione or other anti-diabetic medication). 24552865
Chalasani N, Bonkovsky HL, Fontana R, Lee W, Stolz A, Talwalkar J, Reddy KR, et al.; United States Drug Induced Liver Injury Network. Features and outcomes of 899 patients with drug-induced liver injury: The DILIN Prospective Study. Gastroenterology 2015; 148: 1340-52.e7. (Among 899 cases of drug induced liver injury enrolled in a US prospective study between 2004 and 2013, 4 cases [0.5%] were attributed to antidiabetic medication, but none to a thiazolidinedione). 25754159
Drugs for type 2 diabetes. Med Lett Drugs Ther 2017; 59 (1512): 9-18. (Concise review of drug therapy of type 2 diabetes mentions that two thiazolidediones are available in the US for use as monotherpay or in combination with other hypoglycemic agents; both are associated with weight gain and increased risk for heart failure; no mention of ALT elevations or hepatotoxicity). 28076339
Mak A, Kato R, Weston K, Hayes A, Uetrecht J. Editor's highlight: an impaired immune tolerance animal model distinguishes the potential of troglitazone/pioglitazone and tolcapone/entacapone to cause IDILI. Toxicol Sci 2018; 161: 412-20. (In a murine model with impaired immune tolerance, exposure to troglitazone resulted in ALT elevations and hepatic injury after 3-5 weeks, whereas exposure to pioglitazone did not). 29087505

## OTHER REFERENCE LINKS

1. Recent References on Thiazolidinediones: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=(thiazolidinediones/AE)+AND+Human%5BMH%5D+AND+(drug+induced+liver+injury+OR+jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%222009/12/01%22%5BEDat%5D%3A%222999/12/31%22%5BEDat%5D))
2. Trials on Thiazolidinediones: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=thiazolidinediones)